# Pitolisant

## OVERVIEW

### Introduction

Pitolisant is a histamine type 3 receptor (H_3_) antagonist and inverse agonist that is used in the therapy of excessive daytime sleepiness and cataplexy in patients with narcolepsy. Pitolisant has not been associated with serum enzyme elevations during therapy or to instances of idiosyncratic acute liver injury.

### Background

Pitolisant (pi tol’ i sant) is an orally available, small molecule histamine 3 (H_3_) receptor antagonist and inverse agonist that is used to treat excessive daytime sleepiness in adults with narcolepsy and for cataplexy associated with narcolepsy. Narcolepsy is associated with a deficiency of hypothalamic cells producing orexin, a neuropeptide that acts as an excitatory neurotransmitter on neurons that produce wakefulness. H_3_ receptors are found in the central nervous system where histamine acts as excitatory neurotransmitter promoting wakefulness. Pitolisant was found to increase wakefulness in animal models of narcolepsy and clinical trials demonstrated that it decreased excessive daytime sleepiness in patients with narcolepsy. It also decreased the frequency of episodes of cataplexy, a frequent complication of narcolepsy. Pitolisant was approved in the United States in 2019 as therapy for excessive daytime sleepiness in adults with narcolepsy and was subsequently also approved for treatment of cataplexy due to narcolepsy. Pitolisant is available in tablets of 4.45 and 17.8 mg under the brand name Wakix. The recommended maintenance dose in adults is 17.8 mg once daily after an initial titration period of one week of 8.9 mg daily. Side effects can include headache, insomnia, anxiety, dizziness, increase in appetite, weight gain, abdominal discomfort and nausea. Uncommon, but potentially serious side effects include prolongation of the QTc interval, and it is contraindicated in patients with bradycardia and should be used cautiously in patients receiving other medications that can prolong the QTc interval.

### Hepatotoxicity

In placebo-controlled trials of pitolisant in patients with narcolepsy, minor serum aminotransferase elevations occurred in a small proportion of patients during therapy, but rates of enzyme elevations were similar to those in placebo recipients. In preregistration trials, there were no instances of clinically apparent liver injury or serum aminotransferase elevations with jaundice attributable to pitolisant. Since its approval in Europe in 2017 and the United States in 2020, there have been no publications describing clinically apparent liver injury due to pitolisant.

Likelihood score: E (unlikely cause of acute liver injury with jaundice).

### Mechanism of Injury

The mechanism by which pitolisant might cause liver injury is not known but may be due to a toxic or immunogenic intermediate product of its metabolism. Pitolisant is metabolized in the liver largely by CYP 2D6 and 3A4 and is susceptible to drug-drug interactions with inhibitors or inducers of these enzymes.

Drug Class: CNS Stimulants

Other Drugs for Narcolepsy: Amphetamines, Modafinil, Armodafinil, Methylphenidate, Oxybate, Solriamfetol

## PRODUCT INFORMATION

REPRESENTATIVE TRADE NAMES

Pitolisant – Wakix®

DRUG CLASS

CNS Drugs

COMPLETE LABELING (https://dailymed.nlm.nih.gov/dailymed/search.cfm?label=all&query=Pitolisant)

Product labeling at DailyMed, National Library of Medicine, NIH

## CHEMICAL FORMULA AND STRUCTURE

DRUG | CAS REGISTRY NUMBER | MOLECULAR FORMULA | STRUCTURE
Pitolisant | 362665-56-3 | C17-H26-Cl-N-O

## ANNOTATED BIBLIOGRAPHY

References updated: 18 August 2021

Abbreviations: CPAP, continuous positive airway pressure; H^3^, Histamine-3.

Zimmerman HJ. Hepatotoxicity: the adverse effects of drugs and other chemicals on the liver. 2nd ed. Philadelphia: Lippincott, 1999. (Review of hepatotoxicity published in 1999 before the availability of H_3_ receptor antagonists/inverse agonists).
FDA. https://www.accessdata.fda.gov/drugsatfda_docs/nda/2019/211150Orig1s000MedR.pdf (FDA Drug Approvals website that has product labels [package inserts], letters of approval and full FDA multidisciplinary scientific review of the pitolisant application for safety and efficacy which mentions that rates of ALT elevations during pitolisant therapy were similar to those with placebo and that there was “no pattern of change suggestive of a drug treatment effect”).
Dauvilliers Y, Bassetti C, Lammers GJ, Arnulf I, Mayer G, Rodenbeck A, Lehert P, et al. (2013). HARMONY I study group. Pitolisant versus placebo or modafinil in patients with narcolepsy: a double-blind, randomised trial. Lancet Neurol. (Among 95 adults with narcolepsy and excessive daytime sleepiness in an 8 week controlled trial, decreases in excessive sleepiness scores [Epworth Sleepiness Scale] were greater in patients receiving pitolisant [-5.8] than placebo [-3.4] but similar and not greater than with modafinil [-6.8], while adverse events attributed to pitolisant included headache and abdominal discomfort; no mention of ALT elevations or hepatotoxicity).
Syed YY. (2016). Pitolisant: first global approval. Drugs. (Review of the mechanism of action, development, pharmacology, clinical efficacy and safety of pitolisant shortly after its approval as therapy of narcolepsy by the European Union, mentions adverse events of headache, abdominal pain, increase in appetite, weight gain, insomnia and anxiety; no mention of ALT elevations or hepatotoxicity).
Szakacs Z, Dauvilliers Y, Mikhaylov V, Poverennova I, Krylov S, Jankovic S, Sonka K, et al., HARMONY-CTP study group. (2017). Safety and efficacy of pitolisant on cataplexy in patients with narcolepsy: a randomised, double-blind, placebo-controlled trial. Lancet Neurol. (Among 106 patients with narcolepsy with cataplexy and excessive daytime sleepiness enrolled in a placebo controlled trial, pitolisant [5 to 20 mg daily] led to a greater decrease in cataplexy episodes per week [9.2 to 2.3: -75%] than did placebo [7.3 to 4.5: -38%] and the adverse event rate was the same in both groups; no mention of ALT elevations or hepatotoxicity).
Kollb-Sielecka M, Demolis P, Emmerich J, Markey G, Salmonson T, Haas M. (2017). The European Medicines Agency review of pitolisant for treatment of narcolepsy: summary of the scientific assessment by the Committee for Medicinal Products for Human Use. Sleep Med. (Summary of clinical efficacy and safety of pitolisant in narcolepsy by the European Medicines Agency mentions that adverse events are largely neuropsychiatric such as headache, insomnia, anxiety, irritability, dizziness and depression; no mention of ALT elevations or hepatotoxicity).
Dauvilliers Y, Arnulf I, Szakacs Z, Leu-Semenescu S, Lecomte I, Scart-Gres C, Lecomte JM, et al., HARMONY III study group. (2019). Long-term use of pitolisant to treat patients with narcolepsy: Harmony III Study. Sleep. (Among 102 adults with narcolepsy and excessive daytime sleepiness treated with pitolisant [titrated up to as high as 40 mg daily] for one year, sleepiness and episodes of catalepsy decreased and adverse events were mostly mild-to-moderate with headaches [12%], insomnia [9%], weight gain [8%], anxiety [7%], depression [5%], nausea [5%] while “no safety issues were identified regarding….blood chemistry…”).
Dauvilliers Y, Verbraecken J, Partinen M, Hedner J, Saaresranta T, Georgiev O, Tiholov R, et al. (2020). HAROSA II Study Group collaborators. Pitolisant for daytime sleepiness in patients with obstructive sleep apnea who refuse continuous positive airway pressure treatment. A Randomized Trial. Am J Respir Crit Care Med. (Among 267 patients with obstructive sleep apnea not on CPAP therapy who had excessive daytime sleepiness and were treated with pitolisant or placebo for 12 weeks, improvement in Epworth Sleepiness Scale scores were greater with pitolisant [-6.3 vs -3.6 points], while adverse event rates were similar and there were no changes in “blood chemistry” results).
Thorpy MJ. (2020). Recently approved and upcoming treatments for narcolepsy. CNS Drugs. (Review of the mechanism of action, pharmacology, drug-drug interactions, clinical efficacy and safety of newly approved medications for narcolepsy including pitolisant and solriamfetol: no mention of ALT elevations or hepatotoxicity).
Pépin JL, Georgiev O, Tiholov R, Attali V, Verbraecken J, Buyse B, Partinen M. (2021). Fet al.; HAROSA I Study Group. Pitolisant for residual excessive daytime sleepiness in OSA patients adhering to CPAP: a randomized trial. Chest. (Among 244 patients with obstructive sleep apnea receiving CPAP therapy who had excessive daytime sleepiness and were treated with pitolisant or placebo for 12 weeks, improvements in Epworth Sleepiness Scale were greater with pitolisant than placebo [-6.0 vs -2.6] as were adverse events of headache [15% vs 1.5%] and insomnia [9.3% vs 3.3%]; but “no major changes were found in …laboratory test results during the study”).
(2021). Pitolisant (Wakix) for narcolepsy. Med Lett Drugs Ther. (Concise review of the mechanism of action, and relative efficacy, safety and costs of pitolisant in relation to other medications for narcolepsy shortly after its approval for use in the US, mentions side effects of headache, insomnia, nausea and prolongation of the QTc interval).

## OTHER REFERENCE LINKS

1 Recent References on Pitolisant: from PubMed.gov (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=Pitolisant+AND+Human%5BMH%5D+AND+(drug+induced+liver+injury+OR+jaundice/CI+OR+bile+duct+diseases/CI+OR+liver/DE+OR+liver+diseases/CI)+AND+(%221900/1/1%22%5BEDat%5D:%222999/12/31%22%5BEDat%5D))
2 Trials on Pitolisant: from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=Pitolisant)